# What's New in LiverTox^®^

Updated: 13 Oct 2026

Updated
- Moxidectin 12 Sep 2026
- Brensocatib 07 Sep 2026
- Danicopan 07 Sep 2026
- Vimseltinib 31 Aug 2026
- Enlicitide 27 Aug 2026
- Bortezomib 22 Aug 2026
- Cabozantinib 22 Aug 2026
- Sevabertinib 15 Aug 2026
- Alectinib 09 Aug 2026
- Dicloxacillin 09 Aug 2026
- Nafcillin 09 Aug 2026
- Oxacillin 09 Aug 2026
- Penicillins (2nd Generation) 09 Aug 2026
- Remibrutinib 08 Aug 2026
- Axitinib 05 Aug 2026
- Afatinib 30 Jul 2026
- Vorasidenib 30 Jul 2026
- Lerodalcibep 29 Jul 2026
- Lamotrigine 27 Jul 2026
- Cordyceps 23 Jul 2026